# Cholestatic Hepatitis

Description. The course of illness is marked by cholestasis, even early at the time of onset. The typical presentation of symptoms includes nausea, fatigue and pruritus followed by dark urine and jaundice. The liver enzyme pattern is cholestatic with prominence of alkaline phosphatase and bilirubin elevations. The illness can be prolonged. This pattern of injury is typical of drug induced liver injury, accounting for at least one-third of cases.

Latency to Onset. The time to onset of cholestatic hepatitis is typically 2 to 12 weeks, but may occur up to one year after starting medication.

Symptoms. Symptoms usually begin with fatigue and nausea followed soon after with pruritus, dark urine and jaundice. Immunoallergic features such as rash, fever and eosinophilia may occur.

Serum Enzyme Elevations. Prominence of alkaline phosphatase (Alk P) and GGT elevations of at least 3 times the upper limit of normal (ULN) with variable elevations in ALT, which can be as high as 10 times ULN (400 U/L) early in the course of illness. The ALT divided by Alk P (both expressed as multiples of ULN) or the R ratio should be less than 2.0, but may be higher at the time of onset, as the Alk P usually rises during the first week or two of injury. Thus, assigning a case as having cholestatic liver enzymes should be based on the majority of elevations during the period of illness or jaundice rather than just the initial values. Drug induced cholestatic hepatitis is typically more prolonged that acute hepatocellular hepatitis due to medications, the serum enzymes decreasing slowly with 50% fall within 4 to 12 weeks. Severe cholestatic drug induced liver injury can lead to vanishing bile duct syndrome to variable degrees. Prolonged jaundice may be followed by mild alkaline phosphatase elevations for months to years after symptomatic recovery (and loss of jaundice), which may represent self-limited, mild or "partial" vanishing bile duct syndrome.

Drugs. Medications commonly implicated in causing cholestatic hepatitis include rifampin, the penicillins, amoxicillin/clavulanate, cephalosporins, sulfonylureas, methimazole and many others.

Differential Diagnosis. The major diagnoses that should be considered are biliary obstruction, gallstone disease, malignancy, autoimmune cholestatic syndromes (primary biliary cirrhosis, sclerosing cholangitis), and rare inherited forms of intrahepatic cholestasis.

Criteria for Definition. Elements important in diagnosis of cholestatic hepatitis due to medications include:

1 Cholestatic pattern of serum enzyme elevations (R value <2), with Alk P levels greater than 3 times ULN (>345 U/L) at the time of peak ALT or bilirubin elevation
2 Latency of 2 to 24 weeks
3 Symptoms (if present) of dark urine or pruritus early during course
4 Bilirubin >2.5 mg/dL
5 If liver biopsy is obtained, changes of intrahepatic cholestasis with inflammatory cells but mild to moderate focal hepatocellular necrosis
6 Exposure to an agent known to cause cholestasis

A latency period above 24 weeks or Alk P levels of only 2 times ULN (between 230 and 345 U/L), while ALT levels are less than 400 U/L (<10 times ULN) do not exclude cholestatic hepatitis but make it less probable. Cholestatic forms of drug induced liver injury can present with immunoallergic features, particularly with a short incubation period or upon reexposure to the medication. If the cholestasis is severe, the illness can be prolonged and can lead to vanishing bile duct syndrome. Cholestatic hepatitis is less likely to lead to acute liver failure or death from acute drug induced liver injury than is acute hepatitis due to medications. However, prolonged cholestasis can evolve into vanishing bile duct syndrome and result in chronic liver injury, cirrhosis and need for liver transplantation. Prolonged cholestasis can also be debilitating acutely and contribute to multiorgan failure and death in patients with other serious underlying illnesses.

## Representative Cases

### Case 1. Cholestatic hepatitis after single intravenous infusion of cefazolin.

[DILIN Case: 104-0079]

A 60 year old man received a single intravenous (iv) infusion of cefazolin during outpatient surgery and developed symptoms of liver disease 3 days later. He was healthy without major medical illnesses when he injured his shoulder while playing hockey. As a consequence, he underwent outpatient surgical repair of a torn right supraspinatus muscle under general anesthesia, using inhaled nitrous oxide with intravenous propofol, fentanyl and midazolam. He also received a single iv infusion of 2 grams of cefazolin (a first generation parenteral cephalosporin) for prophylaxis against infection. Other perioperative medications included dimenhydrinate (Dramamine) and hydromorphone. The surgery lasted 5 hours and he recovered without incident, being sent home the same day with a prescription for a combination of acetaminophen (500 mg) and codeine (5 mg) 2 or 3 times daily for pain control, which he took as directed. Three days after surgery, he developed nausea and pruritus and 2 days later noted dark urine and jaundice. On testing, he had moderate elevations in serum aminotransferase and alkaline phosphatase levels and hyperbilirubinemia (Table). He was admitted for evaluation. His past medical history was remarkable for several previous orthopedic procedures. He had a history of asbestos exposure and mild chronic bronchitis for which he used albuterol by inhaler irregularly. He took occasional ibuprofen for muscle aches. He denied alcohol use or exposure to viral hepatitis. On admission to the hospital, he had mild eosinophilia (~640 cells/μL), but no rash or fever. Tests for hepatitis A, B and C were negative as well as autoantibodies. Ultrasound of the abdomen was normal. Importantly, review of two previous surgeries showed that he had received cefazolin at the time of both, and had jaundice following the second surgery that had been attributed to halothane. Careful review of anesthesia records showed no exposure to halogenated anesthetics during this third surgery; the names of the inhalational agent used during previous surgeries were not available.

#### Key Points

Medication: | Cefazolin, 2 grams iv at time of surgery
Pattern: | Initially mixed and then cholestatic (R=2.2→0.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 days
Recovery: | Complete within 8 weeks
Other medications: | Chronically, salbutamol and ibuprofen; perioperatively nitrous oxide, fentanyl, propofol, midazolam, dramamine, acetaminophen with codeine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 65 | 0.4 | Presurgery evaluation
Orthopedic surgery under nitrous oxide and propofol, and iv cefazolin (2 grams)
7 days | 6 days | 194 | 309 | 5.7 | 10% eosinophils
8 days | 7 days | 192 | 240 | 5.3
11 days | 10 days | 193 | 358 | 4.4
2 weeks | 13 days | 116 | 385 | 4.3
3 weeks | 20 days | 92 | 373 | 2.9
4 weeks | 27 days | 92 | 293 | 1.4
2 months | 2 months | 62 | 97 | 0.8 | No symptoms
8 months | 8 months | 20 | 60 | 0.6
Normal Values | | <40 | <140 | <1.2

#### Comment

Cholestatic hepatitis is typically heralded with onset of nonspecific symptoms and pruritus, followed by dark urine and jaundice. The differential diagnosis must rule out biliary obstruction. Common causes of cholestatic hepatitis include penicillin, amoxicillin/clavulanate or a cephalosporin and the jaundice may arise days or even several weeks after the antibiotic is given. Cholestatic hepatitis is generally benign and runs a self limited course. A single, intravenous administration of a cephalosporin at the time of outpatient surgery may be a more common cause of jaundice and liver injury than is currently thought.

### Case 2. Cholestatic hepatitis caused by dicloxacillin.

[Modified from: Kleinman MS, Presberg JE. Cholestatic hepatitis after dicloxacillin-sodium therapy. J Clin Gastroenterol 1986; 8: 77-8. PubMed Citation]

A 56 year old man received a 5 day course of oral dicloxacillin (250 mg four times a day) and 2 weeks later developed gastrointestinal discomfort, followed by fever and then jaundice and itching. He had a history of acute viral hepatitis 22 years ago, but no other significant medical history and had no current risk factors for viral hepatitis. He took no other medications, had no allergies and drank little alcohol. On admission, serum bilirubin was 3.8 mg/dL and it subsequently rose further (Table). Eosinophil counts were normal. Tests for acute hepatitis A and B were negative and abdominal ultrasound was normal. After several weeks, he began to improve and laboratory abnormalities returned to normal 14 weeks after he had started the course of antibiotics.

#### Key Points

Medication: | Dicloxacillin
Pattern: | Mixed initially and then cholestatic (R=2.6 and falling to 0.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Two to three weeks
Recovery: | Complete within 3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
0 | | Dicloxacillin given for 5 days
3 weeks | 2 weeks | 225 | 218 | 3.8 | Eosinophils=487
4 weeks | 3 weeks | 325 | 230 | 8.0
5 weeks | 4 weeks | 50 | 150 | 10.3
7 weeks | 6 weeks | 45 | 165 | 11.8 | R=0.7
8 weeks | 7 weeks | 60 | | 9.8
9 weeks | 6 weeks | 110 | | 5.0
10 weeks | 9 weeks | 80 | 170 | 3.2
12 weeks | 11 weeks | 70 | 135 | 1.8
13 weeks | 12 weeks | 65 | 120 | 1.1
14 weeks | 13 weeks | 38 | 60 | 0.5
Normal Values | | <40 | <100 | <1.2

* Estimates made from Figure 1.

#### Comment

The appearance of jaundice and itching 3 weeks after starting a 5 day course of dicloxacillin with a mixed pattern of serum enzyme elevations (later becoming cholestatic) is fully compatible with dicloxacillin induced liver injury. Recovery was somewhat slow but was complete by 3 months. Idiosyncratic drug induced liver injury from dicloxacillin is rare and only isolated case reports have been published. More common and with a similar pattern of injury are cases of flucloxacillin induced liver injury (which was approved and used in Australia and Europe but not in the United States).

#### Case 3. Cholestatic hepatitis from amoxicillin/clavulanate.

[DILIN Case: 004-002]

A 75 year old man with a history of prostate cancer and regular alcohol use (2 to 3 drinks daily) was given amoxicillin/clavulanate (500 mg/125 mg) for chronic maxillary sinusitis. Because of persistent symptoms, the antibiotic was continued for 31 days. When seen in follow up two weeks later, he complained of jaundice and was admitted to the hospital for evaluation. He had symptoms of dark urine, weakness, and poor appetite. Blood test results showed a total bilirubin of 42.7 mg/dL, ALT 194 U/L, AST 107 U/L, and Alk P 257 U/L. Tests for acute hepatitis A, B and C were negative. Ultrasound of the abdomen showed no evidence of biliary obstruction or gallstones. During the hospitalization, he developed profound anemia and thrombocytopenia requiring blood and platelet transfusions, and he was further treated with corticosteroids and cyclophosphamide. His serum bilirubin peaked at 48.8 mg/dL and remained elevated for several months, while aminotransferase and alkaline phosphatase levels were only modestly elevated (Table). The prothrombin time was elevated (INR 1.4 to 1.6) transiently and he developed mild confusion that was believed to be due to hepatic encephalopathy; he was treated with lactulose. During the hospitalization, he developed renal failure and required dialysis. A liver biopsy was performed and findings were consistent with amoxicillin/clavulanate hepatotoxicity. He was hospitalized for 2 months and required another 2 months to recover fully. When seen 4 months after onset of the jaundice, he was back to his usual state of health and had normal laboratory tests, including normal aminotransferase and alkaline phosphatase levels, normal serum bilirubin and creatinine, and normal hemoglobin and platelet counts.

#### Key Points

Medication: | Amoxicillin/clavulanate 500/125 mg thrice daily for 31 days
Pattern: | Cholestatic (R=1.9)
Severity: | 4+ (jaundice, hospitalization, severe thrombocytopenia and acute renal failure)
Latency: | 45 days, 14 days after stopping
Recovery: | Slowly over 4 months
Other medications: | Guaifenesin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 0 | Amoxicillin/clavulanate stopped
5 weeks | 9 days | Jaundice
6 weeks | 15 days | 126 | 195 | 43.8 | Admission, platelets 2,000
7 weeks | 20 days | 58 | 165 | 48.6
8 weeks | 4 weeks | 59 | 248 | 48.8
9 weeks | 5 weeks | 44 | 198 | 42.4 | Acute renal failure
11 weeks | 7 weeks | 40 | 195 | 19.4 | Liver biopsy
12 weeks | 8 weeks | 40 | 267 | 7.4
14 weeks | 10 weeks | 47 | 242 | 3.6 | Discharged, platelets 376,000
5 months | 4 months | 11 | 81 | 0.6 | Creatinine 2.5
Normal Values | | <42 | <115 | <1.2

#### Comment

This case is an example of severe amoxicillin/clavulanate hepatotoxicity and demonstrates that cholestatic hepatitis is not always benign. Liver histology showed central lobular retention of bile with mixed infiltrates of lymphocytes, neutrophils and eosinophils in portal areas and in areas of focal spotty necrosis in the parenchyma. There was minimal steatosis, no fibrosis and no bile duct damage or peribiliary fibrosis or edema. The findings were consistent with a drug induced intrahepatic cholestasis. The case was typical of amoxicillin/clavulanate hepatotoxicity in its onset 1 to 2 weeks after stopping therapy in an elderly man, without other history or risk factors for liver or biliary disease. The severe thrombocytopenia and anemia were atypical, but similar nonhepatic manifestations of immunoallergic injury have been reported. Important conditions to exclude were biliary obstruction due to malignancy or gallstone disease and viral hepatitis.

### Case 4. Acute cholestatic hepatitis due to chlorpromazine.

[Modified from: Werther JL, Korelitz BI. Chlorpromazine jaundice: analysis of twenty-two cases. Am J Med 1957; 22: 351-66. PubMed Citation] [Case 4]

A 26 year old woman with depression was started on chlorpromazine (75 mg/day) and developed generalized pruritus one week later followed by fever, nausea and dark urine. After 21 days of therapy, she was seen by her physician and chlorpromazine was stopped. There was no history of liver disease or alcohol abuse. She was jaundiced but afebrile and without rash. The liver was enlarged but nontender. Serum bilirubin was 12.4 mg/dL and alkaline phosphatase 36.3 King Armstrong units (normal <13) (Table). A total white blood cell count was normal and eosinophils were 4% (~330/μL). An oral cholecystogram was normal. A liver biopsy showed intrahepatic cholestasis and portal infiltrates populated by eosinophils. Over the next few weeks she began to improve and laboratory test results returned to normal within 10 weeks.

#### Key Points

Medication: | Chlorpromazine (75 mg/day)
Pattern: | Cholestatic (R=unable to calculate)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1-2 weeks
Recovery: | 6 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | Chlorpromazine (75 mg/day) given for 21 days
3 weeks | 4 days | 36.3 | 12.4 | Eosinophils 4%
4 weeks | 11 days | 25.6 | 9.1 | Eosinophils 6%
5 weeks | 18 days | 30.4 | 6.1
6 weeks | 25 days | 19.4 | 3.8
13 weeks | 10 weeks | 7.7 | 0.7
Normal Values | | <13 | <1.2

* Some values estimated from Figure 1 and bilirubin converted from µmol/L to mg/dL.

#### Comment

Chlorpromazine (Thorazine) used to be the most common cause of drug induced liver disease with jaundice in the United States and most Western Countries, but is now rare because phenothiazines are no longer widely used. Chlorpromazine jaundice had a very typical clinical signature of short incubation period (1 to 4 weeks), symptoms of pruritus and jaundice (the itching often arising before jaundice) and a benign, self limited course. This case was published before general availability of serum aminotransferase measurements, and long before availability of commercial assays for hepatitis A (1982), B (1972) and C (1992). Nevertheless, it is entirely typical of drug induced cholestatic hepatitis due to chlorpromazine. Liver injury appears to be far less common with other phenothiazines and is rare with the selective serotonin reuptake inhibitors (SSRIs).

### Case 5. Cholestatic hepatitis due to methimazole.

[Modified from: Mikhail NE. Methimazole-induced cholestatic jaundice. South Med J 2004; 97: 178-82. PubMed Citation]

A 43 year old woman with Graves' disease developed pruritus and jaundice one month after starting therapy with methimazole (10 mg) and propranolol (20 mg) three times daily. She did not have abdominal pain, nausea, fever or rash. She continued taking methimazole for 4 days after the appearance of jaundice and presented to the hospital two weeks later because of persistent jaundice and pruritus. She had no history of liver disease or alcohol abuse and no risk factors for viral hepatitis. She had been clinically hyperthyroid with palpitations, tremor and elevated serum T4 levels [30.7 μg/dL] before therapy and routine liver tests were mildly abnormal (Table). On presentation, she was jaundiced but had no signs of chronic liver disease. Laboratory testing showed elevations in serum direct and total bilirubin and a cholestatic pattern of enzyme elevations. CT imaging of the abdomen showed no evidence of biliary obstruction. Tests for hepatitis A, B and C and autoantibodies were negative. Propranolol therapy was restarted and methimazole was held. She improved and jaundice resolved within 4 and other liver test abnormalities within 8 weeks. After recovery from the liver injury, her hyperthyroidism was treated successfully with radioactive iodine.

#### Key Points

Medication: | Methimazole (30 mg daily)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 month
Recovery: | 2 months
Other medications: | Amlodipine, propranolol (both continued)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 134 | 201 | 0.8
6 weeks | 14 days | 104 | 289 | 16.7 | Admission
| 15 days | 91 | 264 | 14.9
| 18 days | 130 | 233 | 12.6
7 weeks | 20 days | 269 | 235 | 11.4
| 22 days | 248 | 209 | 8.8 | Discharge
8 weeks | 4 weeks | 151 | 150 | 4.7
9 weeks | 5 weeks | 63 | 154 | 1.6
3 months | 8 weeks | 66 | 111 | 0.6
Normal Values | | <75 | <116 | <1.2

#### Comment

This patient developed a typical cholestatic hepatitis one month after starting therapy with methimazole. She had mild enzyme elevations at the time that methimazole was started, possibly related to hyperthyroidism. She delayed in seeking medical attention for almost three weeks, but stopped the medication on her own a few days after she noted jaundice. The initial laboratory results after onset were thus well into the illness and taken approximately 2 weeks after onset and more than a week after stopping the medication. Despite this, the patient was ill for almost two months but recovery was otherwise uncomplicated.

## Hepatic Histology of Cholestatic Hepatitis

[Under Construction]